# Mirtazapine

## OVERVIEW

### Introduction

Mirtazapine is a tetracyclic antidepressant with a somewhat unique mechanism of action. Mirtazapine therapy can be associated with transient asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Mirtazapine (mir taz' a peen) is a tetracyclic derivative with a somewhat unique antidepressant activity in comparison to the selective serotonin reuptake inhibitors (SSRIs) and tricyclic antidepressants. Its mechanism of action is not well defined, but it is a potent antagonist of serotonin 5-HT2 and 5-HT3 receptors and appears to enhance central noradrenergic and serotonergic (5-HT1A) activity with less activity against peripheral receptors. Mirtazapine was approved for use in moderate and severe depression in the United States in 1996 and remains in wide use, with more than 6 million prescriptions being filled yearly. The major indication for mirtazapine therapy is major depressive disorder. Mirtazapine is available as regular and oral disintegrating tablets of 7.5, 15, 30 and 45 mg in multiple generic forms and under the brand name Remeron. The recommended dosage in adults is 15 mg once daily at bedtime, which can be increased to a maximum of 45 mg daily. Common side effects are drowsiness, fatigue, blurred vision, dry mouth, increased appetite and weight gain. Rare, but potentially severe adverse events include suicidal thoughts and behavior, activation of mania, seizures, serotonin syndrome and hypersensitivity reactions including Stevens Johnson Syndrome.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in up to 10% of patients on mirtazapine, but elevations are usually modest and rarely require dose modification or discontinuation. Rare instances of acute, clinically apparent episodes of liver injury with marked liver enzyme elevations with or without jaundice have been reported in patients on mirtazapine. The onset of injury has varied greatly from several months to several years. The pattern of serum enzyme elevations is usually hepatocellular, but mixed forms have also been described. Autoimmune (autoantibodies) and immunoallergic features (rash, fever, eosinophilia) are uncommon.

Likelihood score: C (probable rare cause of clinically apparent liver disease).

### Mechanism of Injury

The mechanism by which mirtazapine causes liver injury is not known. Mirtazapine is extensively metabolized by the liver, mainly via the cytochrome P450 system, predominantly CYP 3A4, and is susceptible to multiple drug-drug interactions with agents that induce or inhibit CYP activity. The metabolic intermediates of mirtazapine may be toxic which could account for its hepatoxicity. In other instances, serum enzyme elevations might be due to nonalcoholic steatohepatitis triggered by weight gain caused by mirtazapine therapy.

### Outcome and Management

The serum aminotransferase elevations that occur on mirtazapine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. Rare instances of acute liver failure and chronic hepatitis have been attributed to mirtazapine therapy. Persons with intolerance to mirtazapine may have similar reactions to other antidepressants and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mirtazapine – Generic, Remeron®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=mirtazapine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Mirtazapine | 61337-67-5 | C17-H19-N3

## ANNOTATED BIBLIOGRAPHY

References updated 20 February 2020

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; no mention of mirtazapine).
Larrey D, Ripault MP. Mirtazapine. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 452. (Review of hepatotoxicity of antidepressants mentions that mirtazapine has been implicated in a small number of cases).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-78. (Textbook of pharmacology and therapeutics).
Montgomery SA. (1995). Safety of mirtazapine: a review. Int Clin Psychopharmacol. (Summary of safety results from prelicensure trials; common side effects were drowsiness, dry mouth, increased appetite and weight gain; annual rate of serum enzyme elevations was 10% with mirtazapine, 12% with amitriptyline and 7% with placebo).
Marttila M, Jaaskelainen J, Jarvi R, Romanov M, Miettinen E, Sorri P, Ahlfors U, et al. (1995). A double-blind study comparing the efficacy and tolerability of mirtazapine and doxepin in patients with major depression. Eur Neuropsychopharm. (In a controlled trial of doxepin vs mirtazapine in 163 patients with depression, there were no statistically significant changes in biochemical tests from baseline in either group and no instances of clinically apparent liver injury).
Fawcett J, Barkin RL. (1998). Review of the results from clinical studies on the efficacy, safety and tolerability of mirtazapine for the treatment of patients with major depression. J Affect Disord. (Review of chemical structure, pharmacology, mechanism of action, efficacy and safety of mirtazapine; side effects more common than with placebo include drowsiness, dry mouth, increased appetite, and weight gain; liver injury and ALT elevations were not mentioned).
Hui CK, Yuen MF, Wong WM, Lam SK, Lai CL. (2002). Mirtazapine-induced hepatotoxicity. J Clin Gastroenterol. (Two cases of mirtazapine hepatotoxicity; 54 year old woman developed jaundice 3 years after starting mirtazapine [bilirubin 28.7 mg/dL, ALT 316 U/L, Alk P 150 U/L, protime 27.8 sec], resolving slowly by 5 months after stopping; 49 year old woman developed jaundice 1 year after starting mirtazapine [bilirubin 8.2 mg/dL, ALT 550 U/L, Alk P 140 U/L, protime 18 sec], with worsening for 2 weeks [bilirubin 35.7 mg/dL], resolving slowly within 3 months of stopping).
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI. (2002). Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 were attributed to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000; mirtazapine not mentioned).
Lucena M, Carvajal A, Andrade R, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; mirtazapine was not specifically mentioned).
Biswas PN, Wilton LV, Shakir SA. (2003). The pharmacovigilance of mirtazapine: results of a prescription event monitoring study on 13554 patients in England. J Psychopharmacol. (Analysis of prescription event monitoring in UK National Health Service between 1997-9 including 13,554 patients who received mirtazapine; 4.2% had adverse event, most common being drowsiness, malaise, dizziness, nausea, weight gain and headache; 12 reports of facial edema and 6 of allergy, but none of hepatitis or jaundice).
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. (2004). Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, only four being due to antidepressants: nefazodone [2], bupropion [1], and paroxetine [1]).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al., Spanish Group for the Study of Drug-Induced Liver Disease. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Reports to a Spanish network found 461 cases of drug induced liver disease, antidepressants accounted for 23 cases [5%], but mirtazapine was not specifically mentioned).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; no antidepressant ranked among the top 21 agents that were linked to at least 50 cases each).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were attributed to paroxetine and 3 to fluoxetine, with a relative risk of injury to rate of use in the population of 3.0 and 1.8 respectively; mirtazapine was not specifically mentioned).
DeSanty KP, Amabile CM. (2007). Antidepressant-induced liver injury. Ann Pharmacother. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents).
Adetunji B, Basil B, Mathews M, Osinowo T. (2007). Mirtazapine-associated dose-dependent and asymptomatic elevation of hepatic enzymes. Ann Pharmacother. (20 year old man developed asymptomatic rises in serum enzymes 3 months after starting mirtazapine [bilirubin 0.4 mg/dL, ALT 182 U/L, Alk P 131 U/L], resolving within 2 months of stopping).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug-Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, antidepressants accounted for 12 cases [4%]: duloxetine [6], bupropion [2], fluoxetine [2], amitriptyline [1], sertraline [1], but none were attributed to mirtazapine).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 3 of which were linked to antidepressants: one each for nefazodone, fluoxetine and venlafaxine).
Rodriguez-Pecci MS, Fuente-Aguado Jde L, Montero-Tinnirello J, Fernandez-Fernandez FJ. (2010). Med Clin (Barc). (63 year old man developed fatigue within 6 months of starting mirtazapine [bilirubin 0.4 mg/dL, ALT 96 U/L, Alk P 455 U/L, GGT 945 U/L], abnormalities resolving within 2 months of stopping).
Kang SG, Yoon BM, Park YM. (2011). Mirtazapine-induced hepatocellular-type liver injury. Ann Pharmacother. (19 year old man developed nausea and ALT elevations within 2 weeks of starting mirtazapine [bilirubin 0.7 mg/dL, peak ALT 358 U/L, Alk P 32 U/L], resolving within 2 weeks of stopping).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of antidepressant induced liver injury).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to mirtazapine).
Montastruc F, Scotto S, Vaz IR, Guerra LN, Escudero A, Sáinz M, Falomir T, et al. (2014). Hepatotoxicity related to agomelatine and other new antidepressants: a case/noncase approach with information from the Portuguese, French, Spanish, and Italian pharmacovigilance systems. J Clin Psychopharmacol. (Among adverse event reports attributed to antidepressants submitted to 4 European pharmacovigilance databases, 3300 [10%] were for hepatotoxicity, rates being highest for agomelatine [14.6%], but also being high for mirtazapine in some databases, 2.0% to 11.8%]).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of the hepatotoxicity of antidepressants mentions that aminotransferase elevations arise in 0.5-3.0% of patients being highest with MAO inhibitors and lower with SSRIs; mentions that all antidepressants have the potential to cause liver injury but risk is highest for nefazodone, imipramine, amitriptyline, duloxetine, bupropion, trazodone and agomelatine).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, only one was due to an antidepressant [amitriptyline] and none to mirtazapine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, xx were attributed to antidepressants, but none to mirtazapine).
Gahr M, Zeiss R, Lang D, Connemann BJ, Hiemke C, Schönfeldt-Lecuona C. (2016). Drug-Induced Liver Injury Associated with antidepressive psychopharmacotherapy: an explorative assessment based on quantitative signal detection using different MedDRA terms. J Clin Pharmacol. (Using data on adverse drug reaction reports from the Uppsala Monitoring Center of WHO, there were higher relative hepatotoxicity reports for nefazodone, agomelatine, many tricyclics and mirtazapine).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported including 39 attributed to mirtazapine among 43,902 patients exposed [0.09%], most cases being asymptomatic and anicteric).
Thomas E, Haboubi H, Williams N, Lloyd A, Ch'ng CL. (2017). Mirtazapine-induced steatosis. Int J Clin Pharmacol Ther. (48 year old woman developed lethargy, peripheral edema, and jaundice while on long term mirtazapine and had steatohepatitis on liver biopsy [bilirubin 11.6 mg/dL, ALT normal, Alk P 149 U/L], improving after stopping, BMI not reported and history of alcoholism in the past).
Chen VC, Lin CF, Hsieh YH, Liang HY, Huang KY, Chiu WC, Lee Y, McIntyre RS, et al. (2017). Hepatocellular carcinoma and antidepressants: a nationwide population-based study. Oncotarget. (Among almost 50,000 cases of hepatocellular carcinoma registered in the Taiwan National Health Insurance Research Database, the rate of antidepressant use was lower than in approximately 250,000 matched controls from the database).
Bunchorntavakul C, Reddy KR. (2017). Drug hepatotoxicity: newer agents. Clin Liver Dis. (Review of hepatotoxicity of recently approved medications mentions that liver injury is rare in recently approved agents and only rare instances have been linked to antidepressant use, highest rates associated with duloxetine).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to antidepressants including citalopram [n=4], sertraline [n=3], amitriptyline [n=3] and paroxetine [n=2], and mirtazapine [n=1] and the combination of both trazodone and mirtazapine [n=1]).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: a cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Using the French National Health Insurance Database, 382 serious liver injuries were found in approximately 5 million persons initiating antidepressant therapy, rates being 32.8 per 100,000 with mirtazapine, 22.2 with venlafaxine, 19.2 for SSRIs and 12.6 with duloxetine).
(2019). Drugs for anxiety disorders. Med Lett Drugs Ther. (Concise review of drugs for anxiety including SSRIs, SNRIs and benzodiazepines including mechanism of action, clinical efficacy, safety and costs; does not mention ALT elevations or hepatotoxicity).
Pladevall-Vila M, Pottegård A, Schink T, Reutfors J, Morros R, Poblador-Plou B, Timmer A, et al. (2019). Risk of acute liver injury in agomelatine and other antidepressant users in four European countries: a cohort and nested case-control study using automated health data sources. CNS Drugs. (Analysis of data sources from 4 European countries identified 3.2 million persons initiating antidepressant therapy among whom there was no increased risk for acute liver injury for agomelatine compared to citalopram, an SSRI with a low rate of hepatotoxicity).
Schwasinger-Schmidt TE, Macaluso M. (2019). Other antidepressants. Handb Exp Pharmacol. (Review of the pharmacology of antidepressants mentions that transient elevations in cholesterol and liver function tests can occur on mirtazapine therapy).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]).

## OTHER REFERENCE LINKS

1 Recent References on Mirtazapine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=mirtazapine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Mirtazapine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=mirtazapine)